# Dihydromyricetin

## OVERVIEW

### Introduction

Dihydromyricetin is a naturally occurring flavonoid found in the many plant species and is thought to be the active ingredient of several traditional Japanese, Chinese, and Korean medicines that are used to treat fever, parasite infections, liver diseases, and hangovers. Dihydromyricetin preparations have not been linked to instances of serum enzyme elevations or clinically apparent liver injury with jaundice.

### Background

Dihydromyricetin (DHM) is a flavonoid found in many plants including Ampelopsis grossedentata (Chinese vine tea), Hovenia dulcis (Japanese raisin tree) and some pinus and Cedrus species. These herbal products are purported to be beneficial for cough, fever, colds, sore throat, vomiting, jaundice, nephritis, and hangovers. The suspected active ingredient is the flavonoid dihydromyricetin, purified preparations of which have been studied extensively in vitro and in vivo. Studies in cell cultures and in animal models have suggested that DHM has antioxidant, antiinflammatory, antibacterial and antineoplastic activities. DHM has been reported to improve glycemic control in diabetic animals, to lower serum cholesterol levels in animals with dyslipidemia, to improve cognitive function in models of brain injury, and to reduce liver injury in animal models of hepatotoxicity and alcoholic liver disease. Despite the many studies of DHM in animal models of disease, there have been few clinical trials of DHM in patients with diabetes, hyperlipidemia, neurologic diseases, or liver injury. In one small placebo-controlled trial of DHM in patients with nonalcoholic fatty liver, DHM resulted in greater improvements in serum aminotransferase levels, in fasting serum glucose and in LDL cholesterol levels without a change in body weight or in hepatic fat concentration as assessed by ultrasound. DHM is not approved for any use or disease in humans in the United States but is available in nutrition centers and on the internet. The typical dose in 300 to 1000 mg daily. The few studies of short term DHM therapy in humans reported no adverse events or evidence to toxicity to date. DHM is also a prominent component of several herbal medications including Japanese raisin tree and Chinese vine tea and is found in low concentrations in many plants, fruits and seeds.

### Hepatotoxicity

DHM has not been subjected to many prospective trials of safety but is widely described as being well tolerated and without side effects. There have been no clinical case reports of clinically apparent liver injury with jaundice attributed to DHM, and it is not mentioned or listed in large case series or systematic reviews of the literature on herbal and dietary supplement induced liver injury. Thus, at this time, there is little evidence that DHM in typical oral doses or as a component of herbal products or teas causes clinically apparent liver injury in humans.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

DHM has not been linked to serum enzyme elevations during therapy or clinically apparent liver injury. The mechanism by which DHM might cause liver injury is not known. DHM is poorly absorbed, is fairly rapidly metabolized, and its metabolic byproducts have not been fully defined.

Drug Class: Herbal and Dietary Supplements

Other names: Ampeloptin, Ampelopsin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dihydromyricetin – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Dihydromyricetin | 27200-12-0 | C15-H12-O8

A polyphenolic hydroxy dihydroflavonol.

## ANNOTATED BIBLIOGRAPHY

References updated: 16 August 2023

Abbreviations: DHM, dihydromyricetin; HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not dihydromyricetin [DHM]).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Among 778 spontaneous reports of adverse reactions to herbal and alterative medicines to a national Swedish Registry, no cases were attributed to DHM). 19650152
Shen Y, Lindemeyer AK, Gonzalez C, Shao XM, Spigelman I, Olsen RW, Liang J. Dihydromyricetin as a novel anti-alcohol intoxication medication. J Neurosci. 2012;32:390-401. (Rats given intraperitoneal injections of DHM had decreased voluntary intake of alcohol, less evidence of alcohol central nervous system effects, and fewer signs of subsequent alcohol withdrawal, the effects were attributed to DHM’s effects on GABA signaling). 22219299
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbal products identified 185 publications on 60 different herbs, herbal drugs and supplements but does not list or mention DHM). 22928722
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury does not mention DHM). 23121117
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies; no mention of DHM). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed specifically to DHM). 25043597
Chen S, Zhao X, Wan J, Ran L, Qin Y, Wang X, Gao Y, et al. Dihydromyricetin improves glucose and lipid metabolism and exerts anti-inflammatory effects in nonalcoholic fatty liver disease: A randomized controlled trial. Pharmacol Res. 2015;99:74-81. (Among 60 Chinese adults with nonalcoholic fatty liver disease treated with DHM [150 mg] or placebo twice daily for 3 months, weight did not change and hepatic steatosis as assessed by ultrasound improved similarly in the two groups, while serum ALT, AST and GGT levels decreased more in the DHM- than placebo treated subjects as did fasting glucose, LDL cholesterol, tumor necrosis factor alpha, CK-18 and FGF21 levels, and there were no adverse events in either group). 26032587
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss DHM). 27402097
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of DHM). 29307848
Ran L, Wang X, Lang H, Xu J, Wang J, Liu H, Mi M, Qin Y. Ampelopsis grossedentata supplementation effectively ameliorates the glycemic control in patients with type 2 diabetes mellitus. Eur J Clin Nutr. 2019;73:776-782. (Among 80 patients with type 2 diabetes on various antidiabetic medications treated with DHM [760 mg] or placebo once daily for 1 month, fasting glucose levels decreased in DHM treated subjects compared to placebo but there were no changes in lipid or insulin levels, and there were “no adverse reactions” in either group). 30089792
Skotnicová A, Boubínová G, Boštíková Z, Dušková Š, Šulc M, Kutinová-Canová N, Mráz J, et al. Does dihydromyricetin impact on alcohol metabolism. Physiol Res. 2020;69(Suppl 4):S573-S581. (Studies in vivo and in vitro in rats found no evidence that DHM affects alcohol metabolism or has hepatoprotective effects against alcohol induced liver injury). 33656905
Silva J, Yu X, Moradian R, Folk C, Spatz MH, Kim P, Bhatti AA, et al. Dihydromyricetin protects the liver via changes in lipid metabolism and enhanced ethanol metabolism. Alcohol Clin Exp Res. 2020;44:1046-1060. (In a mouse model of alcohol induced liver injury, oral administration of DHM was associated with less liver steatosis and triglyceride levels which was attributed to changes in lipid metabolism and enhancement of ethanol metabolism as well as suppression of immune responses). 32267550
Chen J, Wang X, Xia T, Bi Y, Liu B, Fu J, Zhu R. Molecular mechanisms and therapeutic implications of dihydromyricetin in liver disease. Biomed Pharmacother. 2021;142:111927. (Review of the potential mechanisms of action of DHM in treating liver disease as shown in multiple animal models and in vitro systems of cell injury). 34339914
Verster JC, van Rossum CJI, Scholey A. Unknown safety and efficacy of alcohol hangover treatments puts consumers at risk. Addict Behav. 2021;122:107029. (Analysis of over-the-counter or internet available dietary supplements advertised to treat or prevent hangovers [n=82], found that most contained vitamins and minerals, and 49% contained milk thistle, 48% DHM, 45% N-acetyl cysteine [NAC], 27% alpha lipoic acid, and at least two dozen other herbs, but without providing information of concentration and without any clinical studies of efficacy or safety in support of the use of any of the components). 34225031
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on HDS induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; DHM is not listed or discussed). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American Drug-Induced Liver Injury Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3]; DHM is not mentioned). 33434654
Wang Y, Wang J, Xiang H, Ding P, Wu T, Ji G. Recent update on application of dihydromyricetin in metabolic related diseases. Biomed Pharmacother. 2022;148:112771. (Review of the in vitro and in vivo studies of dihydromyricetin demonstrating antiinflammatory, antitumor, antioxidant and antibacterial activity with applications in nonalcoholic fatty liver, alcoholic liver disease, chemical injury to the liver, acute liver failure and liver cancer, “with almost no toxicity”). 35247719
Gong H, Xu H, Li M, Zhang D. Molecular mechanism and therapeutic significance of dihydromyricetin in nonalcoholic fatty liver disease. Eur J Pharmacol. 2022;935:175325. (Review of the possible mechanism of action of DHM in treating nonalcoholic fatty liver from many in vitro and in vivo studies suggests that it has antiinflammatory and antioxidant activities and may act via sirtuin-dependent pathways). 36265611
Al Omran AJ, Watanabe S, Hong EC, Skinner SG, Zhang M, Zhang J, Shao XM, et al. Dihydromyricetin ameliorates social isolation-induced anxiety by modulating mitochondrial function, antioxidant enzymes, and BDNF. Neurobiol Stress. 2022;21:100499. (In mice housed alone suffering from “social isolation-induced anxiety”, administration of DHM decreased evidence of the mouse anxiety as well as changing mitochondrial function, levels of antioxidant enzymes and brain derived neurotrophic factor). 36532369
Miao X, Luo P, Liu J, Wang J, Chen Y. Dihydromyricetin ameliorated nonalcoholic steatohepatitis in mice by regulating the composition of serous lipids, bile acids and ileal microflora. Lipids Health Dis. 2023;22:112. (In mice given a methionine and choline deficient diet, treatment with DHM was associated with similar degrees of weight loss, but less hepatic fat and triglycerides and lower serum ALT [but not AST] levels, which was attributed to less increase in toxic bile acids and lipids and more benign ileal microflora). 37533083

## OTHER REFERENCE LINKS

Recent References on Dihydromyricetin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dihydromyricetin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Dihydromyricetin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dihydromyricetin)